# Ublituximab

## OVERVIEW

### Introduction

Ublituximab is a chimeric monoclonal antibody to CD20, a cell surface marker found on B lymphocytes and plasma cells, which is used to treat adults with relapsing multiple sclerosis. Ublituximab has not been linked to liver enzyme elevations during therapy or to instances of clinically apparent liver injury, but like other monoclonal antibodies to CD20, ublituximab can cause reactivation of hepatitis B.

### Background

Ublituximab (ue” bli tux’ i mab) is a chimeric, glygcoengineered monoclonal IgG1 antibody to the CD20 antigen which is used to treat adults with relapsing multiple sclerosis (MS). Ublituximab binds to the cell surface marker CD20 on B lymphocytes and causes their depletion resulting in a decrease in spontaneous autoantibody production. This monoclonal antibody has been shown to be effective in reducing disease activity in patients with severe forms of relapsing multiple sclerosis, a disease marked by immune dysregulation and production of pathogenic autoantibodies and immune complexes. Ublituximab was approved for use in the United States in 2022 and current indications are for treatment of adult patients with relapsing forms of multiple sclerosis including clinically isolated syndrome, relapsing-remitting disease, and active secondary progressive disease. Ublituximab was the third monoclonal antibody to CD20 approve for use in multiple sclerosis, the others being ofatumumab (Arzerra: 2009) and ocrelizumab (Ocrevus: 2017). Ublituximab is available in under the brand name Briumvi in single dose vials of 150 mg in 6 mL (25 mg/mL). The recommended dose regimen is an initial intravenous infusion of 150 mg followed by an infusion of 450 mg 2 weeks later and then 450 mg every 24 weeks. Premedication with methylprednisone and an antihistamine is recommended for the first two infusions and patients should be monitored for hypersensitivity reactions for at least one hour. Thereafter, premedication should be used as needed for patients who had troublesome reactions during the first two infusions. Other adverse effects include infections, reduction in immunoglobulin levels, bronchitis, cough, fatigue, headache, insomnia, nausea, and herpes zoster. Rare but potentially serious side effects include severe hypersensitivity reactions (angioedema or anaphylaxis), severe infections, reactivation of hepatitis B and other viral (herpes simplex and zoster), fungal, and mycobacterial infections, and possibly fetal-embryonal toxicity. Screening for hepatitis B virus infection and immunoglobulins is recommended before starting therapy. The potential of reactivation of tuberculosis is not clear. Patients receiving ublituximab should receive all appropriate vaccines (inactivated and live) well before starting therapy. Because of the possibility of fetal injury, women of child-bearing potential should be screened for pregnancy before and practice an effective means of birth control during and for six months after ublituximab therapy.

### Hepatotoxicity

In preregistration controlled trials, elevations in serum aminotransferase levels above 3 times the ULN arose in 3.5% of patients receiving ublituximab vs 4.2% of those on teriflunomide, the comparative agent. Two patients receiving ublituximab developed marked ALT and AST elevations accompanied by jaundice, but both were shown to be due to an unrelated cause, one due to acute hepatitis C and the other due to chronic hepatitis B (possibly caused by reactivation). Since its approval and more widescale use, there have been no case reports of liver injury with jaundice linked to ublituximab therapy. Because ublituximab is immunosuppressive, it may cause reactivation of hepatitis B in susceptible persons. Reactivation of hepatitis B can be severe and is sometimes fatal, as has occurred with other monoclonal antibodies directed against CD20 such ofatumumab, ocrelizumab, and rituximab.

Likelihood score: D (possible cause of clinically apparent liver injury as a result of reactivation of hepatitis B).

### Mechanism of Injury

There is little evidence that ublituximab is a cause of idiosyncratic liver injury and mechanisms by which it might occur is not clear but might result from immune modulation. Ublituximab suppresses B cell reactivity and is capable of inducing reactivation of hepatitis B in susceptible patients.

### Outcome and Management

The serum aminotransferase elevations that have been reported during ublituximab therapy were generally transient, mild and asymptomatic and did not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to a careful search for other causes of liver injury and more careful monitoring. Because ublituximab is given every 24 weeks, suspension of infusions while waiting for further diagnostic results or for levels returning to normal or near normal levels is usually unnecessary. There is no evidence of cross sensitivity to hepatic reactions among the various monoclonal antibodies. Although the product label for ublituximab does not recommend baseline screening or regular monitoring of liver tests, it is reasonable to include a metabolic panel with routine liver tests as well as a complete blood count before starting therapy and at the 24-week intervals when the agent is administered. Because ublituximab is immunosuppressive, it may cause reactivation of hepatitis B in susceptible persons. Patients should be screened for hepatitis B virus (HBV) serologic markers before starting therapy. Ublituximab is contraindicated in patients with active hepatitis B, and patients with anti-HBc without HBsAg in serum should be considered for prophylaxis against reactivation or monitored closely for early evidence of an appearance of HBV DNA in serum, which should prompt antiviral therapy with an agent with potent activity against HBV.

Drug Class: Monoclonal Antibodies

Other Anti-CD20 Monoclonal Antibodies for Multiple Sclerosis: Ocrelizumab, Ofatumumab, Rituximab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ublituximab – Briumvi®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ublituximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ublituximab | 1174014-05-1 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2025

Abbreviations: HBV, hepatitis B virus.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents does not mention ublituximab).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and toleragens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
FDA. Clinical Review. 2022. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/761238Orig1s000MedR.pdf (FDA website with product labels and initial multidiscipline clinical review of the safety and efficacy of ublituximab based on results from studies provided by the sponsor in support of its approval as therapy of relapsing multiple sclerosis, mentions that ALT elevations above 3 times ULN arose in 3.5% of patients on ublituximab vs 4.2% of teriflunomide, and 2 cases of marked ALT elevations with jaundice in those on ublituximab were due to acute hepatitis C and chronic hepatitis B [possibly reactivation] and not to drug induced liver injury).
Lovett-Racke AE, Gormley M, Liu Y, Yang Y, Graham C, Wray S, Racke MK, et al. B cell depletion with ublituximab reshapes the T cell profile in multiple sclerosis patients. J Neuroimmunol. 2019;332:187-197. (Analysis of lymphocyte subsets in 40 patients with multiple sclerosis receiving ublituximab demonstrated that the depletion of B cells by the cytolytic monoclonal antibody caused shifts in lymphocyte subsets suggesting that immune regulation was restored). 31077854
Fox E, Lovett-Racke AE, Gormley M, Liu Y, Petracca M, Cocozza S, Shubin R, et al. A phase 2 multicenter study of ublituximab, a novel glycoengineered anti-CD20 monoclonal antibody, in patients with relapsing forms of multiple sclerosis. Mult Scler. 2021;27:420-429. (Among 48 patients with relapsing multiple sclerosis treated with ublituximab in 6 dosing regimens, B cell depletion of 95% occurred in all within 2 weeks and the annualized relapse rate decreased [from 1.45 to 0.07], and while 58% had at least one adverse event, none were serious or resulted in discontinuation; no mention of ALT elevations or hepatotoxicity). 32351164
Faissner S, Gold R. Efficacy and safety of multiple sclerosis drugs approved since 2018 and future developments. CNS Drugs. 2022;36:803-817. (Review of the mechanism of action, efficacy, and safety of newly approved drugs for multiple sclerosis including preliminary data on ublituximab; no mention of ALT elevations or hepatotoxicity). 35869335
Steinman L, Fox E, Hartung HP, Alvarez E, Qian P, Wray S, Robertson D, et al.; ULTIMATE I and ULTIMATE II Investigators. Ublituximab versus teriflunomide in relapsing multiple sclerosis. N Engl J Med. 2022;387:704-714. (Among 1096 adults with relapsing multiple sclerosis treated in two controlled trials of ublituximab vs teriflunomide for up to 95 weeks, the annualized relapse rates were .08 to .09 vs .18 to .19; no mention of ALT elevations or clinically apparent liver injury with jaundice). 36001711
Ublituximab (Briumvi) for relapsing multiple sclerosis. Med Lett Drugs Ther. 2023;65:36-38. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of ublituximab mentions that one patient treated with ublituximab in registration trials developed reactivation of hepatitis B and that its use is contraindicated in patients with active HBV infection). 36877282
Lee A. Ublituximab: first approval. Drugs. 2023;83:455-459. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of ublituximab shortly after its approval for use in multiple sclerosis in the US mentions that serious adverse events can include infusion reactions and severe infections; no mention of ALT elevations or hepatotoxicity). 36920653
Gandelman S, Lenzi KA, Markowitz C, Berger JR. A proposed approach to screening and surveillance labs for patients with multiple sclerosis on anti-CD20 therapy. Neurol Clin Pract. 2024;14:e200241. (Proposal for screening and monitoring laboratory tests in patients with multiple sclerosis receiving monoclonal anti-CD4, including ublituximab, recommends baseline liver tests, complete blood count, absolute B cell count, immunoglobulin levels, HBV markers, varicella zoster virus IgG, JC virus status, and vaccination history and regular monitoring of liver tests and complete blood counts thereafter at 6 month intervals; women of child-bearing potential receiving ublituximab should also have baseline and 6 monthly pregnancy testing). 38204588
Carlson AK, Amin M, Cohen JA. Drugs targeting CD20 in multiple sclerosis: pharmacology, efficacy, safety, and tolerability. Drugs. 2024;84:285-304. (Four monoclonal anti-CD20 are currently used to treat multiple sclerosis including ofatumumab, ocrelizumab, ublituximab, and [off-label] rituximab which have different molecular structures, target epitopes, pharmacology, dose regimens and mode of administration, mechanisms of B cell depletion, risks and immunogenicity; and none have been directly compared for efficacy and safety). 38480630

## OTHER REFERENCE LINKS

1. Recent References on Ublituximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ublituximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ublituximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ublituximab)